# Penicillin G and V

## OVERVIEW

### Introduction

Penicillin G and V are first generation penicillins that are used widely to treat infections due to susceptible organisms and have been linked rarely and only weakly with idiosyncratic liver injury.

### Background

Penicillin G benzathine, potassium, procaine and sodium are currently available in the United States in parenteral formulations for intravenous or intramuscular use. Penicillin V potassium (also called phenoxymethyl penicillin) is a more acid stable and can be administered orally. Both Penicillin G and V are available in multiple generic formulations. The natural penicillins are indicated as therapy for mild-to-severe infections caused by susceptible organisms including (but not limited to) streptococcal infections and pneumonia, enterococcal and non-enterococcal endocarditis, diphtheria, anthrax, bacterial meningitis, Lyme disease, gonorrhea, syphilis, actinomycosis, botulism and others. The first generation penicillins are susceptible to inactivation by beta-lactamase, and resistance is relatively common. The usual doses of intravenous penicillin G are 300,000 to 4 million units every 6 to 8 hours. Benzathine penicillin G is given in a one time dose of 2.4 million units intramuscularly as therapy of primary or secondary syphilis, and as three weekly doses for syphilis of longer duration; it is also used as prophylaxis against rheumatic fever. Penicillin V is available in tablets of 250 and 500 mg and is usually given in doses of 250 to 500 mg every 6 to 8 hours for 7 to 20 days. It is also available as an oral solution. Side effects of penicillin G and V include nausea, diarrhea, gastrointestinal upset, headache, dizziness, rash and hypersensitivity reactions. Severe adverse events include anaphylaxis which can be severe and even fatal, angioedema, pseudomembranous colitis, C. difficile infection and Jarisch-Herxheimer reactions.

### Hepatotoxicity

Rare instances of idiosyncratic liver injury have been reported in persons receiving the first generation penicillins. Many case reports predated availability of serologic testing for viral hepatitis and many described patients with multiple reasons for having liver disease (such as sepsis) and who were receiving other potentially hepatotoxic agents. Three distinct forms of liver injury can occur with the first generation penicillins: (1) transient, asymptomatic elevations in serum aminotransferase levels with prolonged high doses of parenteral penicillin, (2) minor liver injury associated with severe hypersensitivity reactions, and (3) idiosyncratic, delayed cholestatic hepatitis. These three forms of injury probably occur with all four generations of penicillin, some being more common with one form of penicillin than another.

High doses of intravenous and intramuscular penicillin can be associated with serum aminotransferase elevations that are usually asymptomatic and resolve rapidly with stopping therapy or switching to another antibiotic (Case 1). Jaundice and elevations in alkaline phosphatase are usually absent or mild. This type of hepatotoxicity is most common with oxacillin and carbenicillin, but can occur with parenteral forms of the first generation penicillins as well. This form of injury appears to be direct hepatotoxicity.

Patients with severe hypersensitivity reactions to penicillin, such as Stevens-Johnson syndrome or anaphylaxis, may have an accompanying liver injury and jaundice, but it is not clear whether this represents true penicillin hepatotoxicity or a complication of hyperthermia, shock and generalized immune reactivity. Generalized allergic reactions to penicillin may be accompanied by granulomas in the liver, spleen and kidney, but are usually without evidence of specific hepatitis injury. Virtually all of the penicillins are associated with hypersensitivity reactions, but liver injury is usually overshadowed by the allergic complications (rash, fever, anaphylaxis).

Finally, isolated case reports have shown that the first generation penicillins can cause a delayed cholestatic hepatitis that probably represents idiosyncratic hepatotoxicity. Symptoms of nausea, abdominal discomfort, jaundice and pruritus generally arise 1 to 4 weeks after starting therapy, and often a few days or weeks after completing a course. The serum enzyme pattern is usually cholestatic, but may be mixed or hepatocellular if tested soon after onset. Immunoallergic features are common, but autoantibody formation is rare. Most cases are mild-to-moderate in severity and resolve rapidly (Case 2). This delayed form of idiosyncratic cholestatic hepatitis is typical of many penicillins and cephalosporins, varying in frequency with the specific form. Idiosyncratic, cholestatic hepatitis is quite rare with the natural penicillins, more common with certain broad spectrum penicillins (cloxacillin, flucloxacillin) and is most common with amoxicillin with clavulanic acid.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the idiosyncratic, cholestatic liver injury associated with penicillin is probably hypersensitivity or allergy. No cases of rechallenge or reexposure have been reported. The serum aminotransferase elevations that occur with high doses of parenteral penicillin are likely due to direct hepatotoxicity.

### Outcome and Management

The asymptomatic rise in serum aminotransferase levels that occurs with high dose penicillin therapy usually resolves rapidly once penicillin is stopped. These patients may tolerate another form of penicillin without recurrence. In the few cases of cholestatic hepatitis that have been described with the first generation penicillins, patients have recovered although recovery was slow in some instances (2 to 6 months). Fatal cases of penicillin associated liver injury have been described, but usually in association with severe allergic reactions such as Stevens-Johnson syndrome in which shock and ischemic hepatitis may have contributed to the outcome. Patients with idiosyncratic liver injury attributed to penicillin should not be reexposed to other penicillins and given cephalosporins only with careful monitoring.

Drug Class: Antiinfective Agents, Penicillins (First Generation)

## CASE REPORTS

### Case 1. Serum aminotransferase elevations attributed to penicillin therapy.(1)

A 54 year old man with pyogenic vertebral spondylitis developed rising serum aminotransferase levels approximately 3 weeks after starting a course of high dose intravenous benzylpenicillin. On admission, and before starting penicillin, he was febrile and complained of fatigue and low back pain. He had no history of alcohol abuse or previous allergic reactions to medications or liver disease. Serum ALT was elevated (Table), but levels fell into the normal range as the infection came under control with antibiotic therapy. After 4 weeks of penicillin therapy, serum ALT levels were found to be elevated in association with marked eosinophilia, but the patient had no symptoms of liver disease and was not jaundiced. Penicillin was continued for another two weeks, but when ALT levels continued to rise antibiotic therapy was changed to a cephalosporin. Serum aminotransferase levels and eosinophilia promptly resolved. Tests for hepatitis A, B and C were negative as were autoantibodies. The patient received several other medications and underwent minor surgery under propofol and alfentanil anesthesia a few days before the onset of the marked ALT elevations. In follow up, he recovered from the infection and had normal liver tests and repeat viral serology was negative.

#### Key Points

Medication: | Penicillin G benzathine (5 MU iv every 6 hours)
Pattern: | Hepatocellular (no alkaline phosphatase elevations)
Severity: | 1+ (serum enzyme elevations without jaundice)
Latency: | 3 weeks
Recovery: | Somewhat more than 3 weeks
Other medications: | Ibuprofen, ranitidine, low molecular weight heparin, chloral hydrate, diazepam and, on day 21, propofol and alfentanil anesthesia.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL)** | Other
Pre | Pre | 106 | 159 | 0.6 | 0.2% eosinophils
Benzylpenicillin (5 MU iv q 6 hr) started for Streptococcal pyogenic vertebral spondylitis
5 days | | 40
11 days | | 30 | Normal
17 days | | 25
21 days | | 25
General anesthesia with propofol and alfentanil for minor surgery (~ day 26)
29 days | | 423 | 101 | 0.5 | 13% eosinophils
32 days | | 570
35 days | | 610
40 days | 0 | 680 | | | Penicillin stopped, ceftriaxone started
45 days | 4 days | 600
48 days | 7 days | 400
56 days | 15 days | 230
2 months | 1 month | 160
Normal Values | | <37 | <109 | <1.2

* Estimates made from Figure 1.

** Bilirubin converted from µmol (1 mg/dL=17.1 µmol/L).

#### Comment

The asymptomatic rise in serum aminotransferase levels after 4 weeks of high dose penicillin therapy and their fall once it was stopped is suggestive of penicillin induced direct hepatic injury. The onset and pattern of hepatic injury resembled the common hepatotoxicity of oxacillin with asymptomatic rises in aminotransferases that decrease rapidly when stopped and are often associated with eosinophilia. In the current case, other diagnoses could not be completely ruled out such as drug induced liver disease from other medications (low molecular weight heparin) or an underlying condition that led to the baseline, pre-penicillin ALT elevations.

### Case 2. Cholestatic hepatitis attributed to penicillin therapy.(2)

A 19 year old man took one tablet of penicillin for a sore throat and developed headache and nausea followed over the next two days by fever and jaundice. He had received two injections of Penicillin G one month previously without incident. He denied previous history of liver disease or penicillin allergy and had no risk factors for viral hepatitis. On admission to the hospital, he was febrile, jaundiced and had a generalized skin rash. He had tender hepatomegaly and splenic enlargement as well as cervical adenopathy. Blood tests showed elevations in serum bilirubin, but mild increases in serum enzymes. He recovered rapidly from the symptoms of fever and prostration, but remained jaundiced for several months. Three liver biopsies were performed; the initial biopsy showed cholestasis with moderate lymphocyte and eosinophil infiltrations; the follow up biopsies showed gradual improvement. During follow up, his serum bilirubin levels were intermittently elevated and alkaline phosphatase levels were minimally increased, but he was asymptomatic, afebrile and had normal ALT levels.

#### Key Points

Medication: | Oral penicillin (200,000 U)
Pattern: | Mixed (R=2.1)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 days
Recovery: | More than 3 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Took a single table of penicillin for sore throat
4 days | 3 days | 96 | 105 | 7.3 | Fever to 40 ^o^C
8 days | 7 days | 48 | 82 | 3.6
25 days | 24 days | 31 | 51 | 3.1
2 months | 2 months | 17 | 58 | 1.9
3 months | 3 months | 9 | 56 | 0.8
5 months | 5 months | 9 | 69 | 0.6
11 months | 11 months | 9 | 68 | 1.9
Normal Values | | 1-17 | 10-40 | <1.2

#### Comment

A dramatic example of immunoallergic, cholestatic hepatitis arising within days of taking a single dose of penicillin. The pattern of serum enzyme elevations and liver histology was fully supportive of a drug induced liver injury and there was no evidence of other forms of liver disease (although no imaging of the gallbladder was mentioned). The onset with fever and rash suggests hypersensitivity and are typical if not universal with penicillin associated acute liver injury. The short latency (4 days) is typical of cases with reexposure to the responsible agent; with first exposure, the latency is typically 2 to 4 weeks.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Various Generic

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=first+generation+penicillins)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Penicillin G (Benzylpenicillin) | 61-33-6 | C16-H18-N2-O4-S
Penicillin G Sodium | 69-57-8 | C16-H18-N2-O4-S
Penicillin G Potassium | 113-98-4 | C16-H18-N2-O4-S.K
Penicillin V | 87-08-1 | C16-H18-N2-O5-S
Penicillin V Potassium | 132-98-9 | C16-H17-K-N2-O5-S C16-H17-N2-O5-S.K C16-H18-N2-O5-S.K

## CITED REFERENCES

1 Bauer TM, Bircher AJ. (1997). Drug-induced hepatocellular liver injury due to benzylpenicillin with evidence of lymphocyte sensitization. J Hepatol.
2 Girard JP, Haenni B, Bergoz R, Kapanci Y, Cruchaud A. (1967). Lupoid hepatitis following administration of penicillin. Case report and immunological studies. Helv Med Acta.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2020

Zimmerman HJ. Penicillins. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 595-6. (Expert review of penicillins and liver injury published in 1999; liver injury from penicillin is rare and usually associated with allergic reactions).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that liver injury from the natural penicillins is rare, with both hepatocellular and cholestatic patterns being described).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Howells L, Kerns JDO. (1946). Hepatitis after penicillin injection. Lancet. (Outbreak of hepatitis after penicillin injections at venereal disease centers, arising 62 to 157 days afterwards with jaundice lasting 10-44 days; "As a routine each syringe is used for about 5 patients, the syringe being boiled frequently, but not necessarily between each case"; an unfortunate example of iatrogenic spread of hepatitis B).
Rabinovitch J, Snitkoff M. (1948). Acute exfoliative dermatitis and death following penicillin therapy. J Am Med Assoc. (72 year old woman developed generalized pruritus 7 days after completing an 11 day course of penicillin with fever, confluent exfoliative rash, progressive abdominal pain, pneumonia, jaundice, coma and death; difficult to say whether jaundice was due to penicillin reaction vs vascular collapse and sepsis).
Felder SL, Felder L. (1950). Unusual reaction to penicillin. J Am Med Assoc. (53 year old man developed rash 10 days after starting intramuscular procaine penicillin with fever, giant urticaria, lymphadenopathy and Alk P 3 times ULN, but no jaundice, resolving within 2 weeks of stopping with conservative therapy using epinephrine and antihistamines).
Waugh D. (1952). Myocarditis, arteritis, and focal hepatic, splenic, and renal granulomas apparently due to penicillin sensitivity. Am J Pathol. (60 year old man with multiple medical problems developed fever, eosinophilia and rash within hours of a penicillin injection requiring corticosteroids; sudden unexplained death 13 days later allowed for autopsy that showed interstitial myocarditis and arteritis with granulomas in liver, kidney and spleen, but no hepatitis or cholestasis).
Murphy ES, Mireles M. (1962). Shock, liver necrosis, and death after penicillin injection. Arch Pathol. (66 year old woman with known penicillin allergy, given penicillin after surgery developed anaphylaxis with shock and diffuse bleeding, developing jaundice and dying several days later; autopsy showed centrolobular necrosis; unclear whether jaundice due to penicillin hepatotoxicity or ischemic liver injury, the autopsy favoring the later).
Vardivia-Barriga V, Feldman A, Orellana J. (1963). Generalized hypersensitivity with hepatitis and jaundice after the use of penicillin and streptomycin. Gastroenterology. (25 year old woman had acute allergic reaction after an injection of penicillin and streptomycin becoming jaundiced within 2 days; other diagnoses could not be excluded in this early case).
Girard JP, Haenni B, Bergoz R, Kapanci Y, Cruchaud A. (1967). Lupoid hepatitis following administration of penicillin. Case report and immunological studies. Helv Med Acta. (19 year old man developed fever, nausea and abdominal pain a few hours after a single dose of oral penicillin with jaundice arising 2 days later with prolonged course, many in vitro assays for penicillin allergy and three liver biopsies done; clearly not “lupoid” hepatitis, but reasonably convincing case of drug induced prolonged cholestasis and possibly vanishing bile duct syndrome: Case 2).
Goldstein LI, Ishak KG. (1974). Hepatic injury associated with penicillin therapy. Arch Pathol. (Often cited paper describes 42 year old man who developed fever, arthralgias and mild alkaline phosphatase elevations [3 times ULN] with normal bilirubin [0.7 mg/dL] and ALT [40 U/L] 8 days after starting penicillin; a liver biopsy showed lobular unrest and mild hepatocyte injury).
Beeley L, Gourevitch A, Kendall MJ. (1976). Jaundice after oral penicillin. Lancet. (Letter describing 36 year old woman who developed fever, rash and prostration after 48 hours of penicillin V [250 mg four times a day] with bilirubin 6.1 mg/dL, AST 62 U/L, alkaline phosphatase 40 U/L, resolving within 3 weeks).
Paine TF. (1978). Updating the side effects of the penicillins. Zhonghua Min Guo Wei Sheng Wu Xue Za Zhi. (Review article mentions liver injury with high dose intravenous penicillins).
Williams CN, Malatjalian DA. (1981). Severe penicillin-induced cholestasis in a 91-year-old woman. Dig Dis Sci. (91 year old woman received cloxacillin for 9 days followed by penicillin G for 5 days, developing symptoms by day 3 with subsequent cholestatic hepatitis, cloxacillin being the more likely culprit).
Roberts J, Bianco MM, Fine J. (1985). Fatal anaphylactic reaction to oral penicillin: report of case. J Am Dent Assoc. (30 year old woman developed anaphylaxis and cardiopulmonary arrest within few minutes of single dose of Pen V; attempts at resuscitation failed; no mention of liver injury. Penicillin accounts for 75% of anaphylactic deaths, 400-800/year, and anaphylaxis incidence is 1-4/1000 exposures).
Friis H, Andreasen PB. (1992). Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med. (Adverse drug reaction reports in Denmark between 1978 and 1987; no mention of penicillins).
Oñate J, Montejo M, Aguirrebengoa K, Ruiz-Irastorza G, González de Zárate P, Aguirre C. (1995). Hepatotoxicity associated with penicillin V therapy. Clin Infect Dis. (67 year old woman with actinomycosis was given penicillin G and then penicillin V; 10 days after starting she developed abdominal pain and at 15 days had abnormal liver tests [bilirubin 1.3 mg/dL, ALT 3073 U/L, Alk P normal], resolving after being switched to erythromycin).
Pillans PI. (1996). Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J. (Adverse drug reaction reports identified 943 cases of liver injury over 21 year period in New Zealand; no mention of penicillin).
Bauer TM, Bircher AJ. (1997). Drug-induced hepatocellular liver injury due to benzylpenicillin with evidence of lymphocyte sensitization. J Hepatol. (54 year old man with osteomyelitis was started on benzylpenicillin [5 MU intravenously every 6 hours] and after 21 days developed eosinophilia and elevated liver tests [bilirubin 0.5 mg/dL, ALT 423 U/L, Alk P 101 U/L], resolving with stopping penicillin; on follow up he had positive lymphocyte stimulation test to benzylpenicillin, negative to amoxicillin and cephalosporin).
Andrade RJ, Guilarte J, Salmerón FJ, Lucena MI, Bellot V. (2001). Benzylpenicillin-induced prolonged cholestasis. Ann Pharmacother. (28 year old woman with Streptococcal pharyngitis was given a single intramuscular injection of benzylpenicillin and developed abdominal pain, fever and jaundice 5 days later [bilirubin 7.6 mg/dL, ALT 357 U/L, Alk P 844 U/L, 1% eosinophils]; jaundice resolved rapidly, but liver enzymes were elevated for 18 months).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; one case was attributed to Penicillin V, but no details given).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antimicrobials accounted for 45% of cases with 23 single agent cases due to amoxicillin/clavulanate, 13 nitrofurantoin, 10 fluoroquinolones, 9 macrolides, 9 sulfonamides, 5 cephalosporins, 3 oxacillin, 2 doxycycline, 2 amoxicillin, and one each for gentamicin, imipenem, and clindamycin, but none from first generation penicillins).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but only two due to amoxicillin and none attributed to natural penicillins).
Leitner JM, Graninger W, Thalhammer F. (2010). Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection. (Review of mechanisms of liver injury due to antibacterial agents; first generation penicillins are not discussed).
Ferrajolo C, Capuano A, Verhamme KMC, Schuemie M, Rossi F, Stricker BH, Sturkenboom CJM. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse drug reports in children in a worldwide pharmacovigilance database, 6595 [1%] were for hepatic injury and antibacterials accounted for 11%, those with the highest adjusted odds ratios being aztreonam, erythromycin, ceftriaxone and minocycline; no mention of penicillins).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 due to amoxicillin/clavulanate, 1 to dicloxacillin [2nd generation] and 1 to phenoxymethylpenicillin [1st generation], the latter two cases being anicteric; none were attributed to a 4th generation penicillin).
Sistanizad M, Peterson GM. (2013). Drug-induced liver injury in the Australian setting. J Clin Pharm Ther. (Among 17 persons with suspected drug induced liver injury seen over at 12 month period at a referral hospital in Tasmania, 11 were attributed to antibiotics including 4 to flucloxacillin, 2 amoxicillin with clavulanate, 2 amoxicillin, and 1 each to rifampin, moxifloxacin and ciprofloxacin; none to 1st generation penicillins).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, including one to benzathine penicillin and 3 to amoxicillin/clavulanate).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics of which 106 [12%] were due to penicillins including one to 1st, three to 2nd [all due to oxacillin], 97 to 3rd [91 to amoxicillin/clavulanate, and 6 to amoxicillin alone] and five to 4th generation penicillins [all 5 to piperacillin/tazobactam]).
Guéant JL, Romano A, Cornejo-Garcia JA, Oussalah A, Chery C, Blanca-López N, Guéant-Rodriguez RM, et al. (2015). HLA-DRA variants predict penicillin allergy in genome-wide fine-mapping genotyping. J Allergy Clin Immunol. (In a genome wide association study of 387 patients with immediate allergic reactions to beta-lactam antibiotics, several class 2 HLA associations [HLA-DRA regions] were found for penicillin responses, but they did not apply to cephalosporin cases).
Björnsson ES. (2016). Hepatotoxicity by drugs: the most common implicated agents. Int J Mol Sci. (Review of the most common causes of drug induced liver injury based upon categorization from LiverTox, amoxicillin/clavulanate but not other forms of penicillin were in the top category of causes of liver injury [likelihood scores of A, with more than 100 cases published in the literature]).
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al., International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. (2017). Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology. (A genome wide association study done on 862 Caucasian patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in those with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine).
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. (2015). Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia including 58 of 207 [28%] who received “penicillins” of whom 3 developed signs of “possible” DRESS syndrome; specific penicillins accounting for the cases were not provided).
Tailor A, Faulkner L, Naisbitt DJ, Park BK. (2015). The chemical, genetic and immunological basis of idiosyncratic drug-induced liver injury. Hum Exp Toxicol. (Review of mechanisms of idiosyncratic drug induced liver injury focusing upon chemically reactive drug metabolites and genetic associations, particularly those with HLA alleles that implicate the adaptive immune response).
Wilkinson J, Zainal A, Naqvi SY. (2016). Penicillin-induced liver injury during treatment for ocular neurosyphilis. BMJ Case Rep. (51 year old man with ocular neurosyphilis developed fever and fatigue 10 days after starting a regimen of 60 mg of prednisone and 24 million units of iv penicillin G daily [bilirubin 1.2 rising to 2.3 mg/dL, ALT 1743 to 2727 U/L, Alk P 68 U/L, INR 1.2], improving rapidly once penicillin was discontinued).
Takeuchi Y, Shinozaki T, Kumamaru H, Hiramatsu T, Matsuyama Y. (2018). Analyzing intent-to-treat and per-protocol effects on safety outcomes using a medical information database: an application to the risk assessment of antibiotic-induced liver injury. Expert Opin Drug Saf. (Cohort matching of cases with vs without antibiotic therapy in a large electronic medical record database from the University of Tokyo Hospital from 2011 to 2015 with adjustments, found rates of liver test abnormalities within 30 days of starting penicillins [25.2 per 1000] were higher than that of fluoroquinolones [11.4] and macrolide antibiotics [8.1] as well as controls [6.5 to 7.1]).
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al., Drug-Induced Liver Injury Network (DILIN) investigators. (2019). International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions).

## OTHER REFERENCE LINKS

1 Recent References on Penicillin G and V: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(penicillin+G/AE+%5BMH:noexp%5D+OR+penicillin+V/AE+%5BMH:noexp%5D+)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Penicillin G and V: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Penicillin+G+OR+Penicillin+V)